# Chlorzoxazone

## OVERVIEW

### Introduction

Chlorzoxazone is a centrally acting muscle relaxant commonly used for low back pain. Chlorzoxazone has been linked to rare instances of acute liver injury, a few of which have been fatal.

### Background

Chlorzoxazone (klor zox' a zone) acts centrally rather than directly on muscles to relieve muscle spasms, either through its sedative effects or other unknown mechanisms. Chlorzoxazone is indicated for therapy of low back pain and muscle spasms, although its overall efficacy is considered only fair. Chlorzoxazone was approved for use in the United States in 1958 and is still widely used. It is available in various generic forms and previously under the brand names of Parafon Forte and Remular in tablets of 250 or 500 mg. The usual recommended dose in adults is 250 to 500 mg orally three to four times daily, reducing the dose to lowest effective level once a response occurs. Chlorzoxazone is typically given for 1 to 4 weeks only. Common side effects of chlorzoxazone include dizziness, drowsiness, headache, fatigue, and tremors. Rare but potentially severe adverse events include acute hypersensitivity reactions and liver injury. The product label for chlorzoxazone now has a warning regarding liver injury recommending that patients report any symptoms of liver injury that arise during therapy and stop therapy if serum ALT, AST, alkaline phosphatase or bilirubin levels become abnormal.

### Hepatotoxicity

There have been no adequate prospective studies demonstrating the rates of ALT or AST elevations on chlorzoxazone therapy. Rare instances of clinical apparent liver disease due to chlorzoxazone have appeared, including fatal cases. While case reports have been few, in many instances chlorzoxazone was clearly implicated; furthermore, a related muscle relaxant with similar structure (zoxazolamine) was withdrawn from use in 1961, largely because of hepatotoxicity. The usual latency period to onset of liver injury is 1 to 4 weeks, and the pattern of disease is typically hepatocellular with marked elevations in ALT levels and jaundice, but minimal increases in alkaline phosphatase. Cholestatic enzyme elevations after exposure to chlorzoxazone have also been described. Allergic manifestations (rash and fever) are common, particularly in cases with a short latency (Case 1); autoantibodies are rare. Recovery is rapid once chlorzoxazone is stopped, but fatal cases have been reported, with disease progression despite early discontinuation of the agent (Case 2). There is rapid recurrence of injury with reexposure, often accompanied by fever.

Likelihood score: A (Well established cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of acute hepatic injury from chlorzoxazone is unknown, but is clearly idiosyncratic and likely due to hypersensitivity.

### Outcome and Management

The idiosyncratic liver injury due to chlorzoxazone ranges from mild, self-limited hepatitis to severe, protracted liver injury leading to death or need for liver transplantation. Patients who receive chlorzoxazone should be warned about the possibility of liver injury and instructed to report any symptoms of hepatic injury that arise on therapy. If liver test abnormalities arise, therapy should be discontinued promptly. Rechallenge leads to rapid return of hepatic injury and should be avoided. No cross reactivity with other muscle relaxants has been identified.

Drug Class: Muscle Relaxants

## CASE REPORTS

### Case 1. Skin rash and cholestatic pattern of serum enzyme elevations from chlorzoxazone.(1)

A 77 year old woman was treated with a combination of chlorzoxazone, dextropropoxyphene and aspirin ("Paraflex Compound") for acute neck pains and developed fever and rash four days later. The medications were continued and one week later she was still febrile and was found to have abnormal liver tests with marked elevations in alkaline phosphatase (6.5 fold elevated) and gamma glutamyl transpeptidase (8-fold increased), with minimal increases in ALT and AST and normal bilirubin. Chlorzoxazone was stopped. The rash was considered to be erythema multiforme. She had a past medical history of osteoporosis and had received aspirin and nonsteroid antiinflammatory agents in the past. She tested negative for hepatitis markers and for autoantibodies. The fever and rash resolved within 1 to 2 weeks of stopping the medication. In follow up, all laboratory tests returned to normal. She later received aspirin without untoward reaction.

#### Key Points

Medication: | Chlorzoxazone (in combination)
Pattern: | Cholestatic (R=0.3)
Severity: | 1+ (enzyme elevations only)
Latency: | 1 week
Recovery: | Complete within several months
Other medications: | Aspirin, dextropropoxyphene

#### Laboratory Values

Time After Starting
Fever and rash arising after 4 days
11 days | 0 | 84 | 750 | 0.6 | Rash and fever
2 weeks | 3 days | 60 | 600 | 0.4
3 weeks | 8 | 24 | 500 | 0.5
| 11 | 12 | 350 | 0.4 | Asymptomatic
5 weeks | 4 weeks | 12 | 167 | 0.5
8 weeks | 7 weeks | 18 | 142 | 0.4
10 weeks | 9 weeks | 12 | 122 | 0.6
Normal Values | | <42 | <115 | <1.2

* Converted from μkat/L (0.7=42) and μmol/L (17=1.0).

#### Comment

This case was identified when the patient developed drug rash and fever. She was not jaundiced, but serum alkaline phosphatase levels were high typical of a cholestatic reaction (also confirmed by the elevations in GGT). Once the medication was stopped, she became asymptomatic within a few weeks, but alkaline phosphatase levels took longer to return to normal. Because she also received dextropropoxyphene, one cannot consider the case definitely due to chlorzoxazone.

### Case 2. Acute liver failure due to chlorzoxazone.(2)

A 38 year old woman developed nausea, vomiting and progressive jaundice 6 weeks after starting chlorzoxazone (500 mg twice daily) for low back pain. Her other medical conditions included hypertension, gastrointestinal reflux and atopic dermatitis. Her medications included hydrochlorothiazide, pantoprazole, iron sulfate and skin creams. She denied taking herbal remedies or other over-the-counter products. She had no history of liver disease, alcohol abuse, risk factors for viral hepatitis or drug allergies. When initially seen she was jaundiced and lethargic. Laboratory results showed total bilirubin of 19.9 mg/dL, ALT 1029 U/L, AST 846 U/L and prothrombin time 32.6 seconds. Because of progressive symptoms and worsening, she was referred to a liver transplant center. On admission, she was deeply jaundiced and had mild asterixis. She had no fever or rash. Tests for hepatitis A, B and C were negative as were antinuclear and smooth muscle antibodies. A CT scan of the abdomen showed a mild amount of ascites and a nodular liver, but no evidence of biliary obstruction. Two weeks later and within 16 days of onset she underwent emergency liver transplantation. The transplant was successful and she left the hospital in good condition.

#### Key Points

Medication: | Chlorzoxazone (1000 mg daily)
Pattern: | Hepatocellular
Severity: | 5+ (liver transplantation)
Latency: | 6 weeks
Recovery: | Incomplete
Other medications: | HCTZ, iron, pantoprazole

#### Laboratory Values

Time After Starting
Nausea and vomiting starting 6 weeks after starting chlorzoxazone
6 weeks | 0 | 1029 | 32.6 | 19.9 | Admission
| 4 days | 1014 | 32.6 | 17.9 | Transfer
8 weeks | 16 days | 93 | 36.8 | 4.8
9 weeks | 19 days | Liver transplantation
Normal Values | | <42 | <14 | <1.2

#### Comment

A young woman developed acute liver failure with an abrupt onset and progressive course 6 weeks after starting chlorzoxazone. Medical evaluation showed no other cause for the acute liver failure. Despite prompt discontinuation of the muscle relaxant, she had a rapidly progressive course.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Chlorzoxazone – Generic, Parafon Forte®

DRUG CLASS

Autonomic Agents: Muscle Relaxants, Central

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=chlorzoxazone)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Chlorzoxazone | 95-25-0 | C7-H4-Cl-N-O2 | SID: 134971727

## CITED REFERENCES

1 Lindholm L. (Fever, skin and liver reactions in a patient treated with Paraflex comp.) Lakartidningen 1979; 76: 2795-6. 160967
2 Jackson J, Anania FA. Chlorzoxazone as a cause of acute liver failure requiring liver transplantation. Dig Dis Sci 2007; 52: 3389-91. 17390222

## ANNOTATED BIBLIOGRAPHY

References updated: 07 July 2026

Zimmerman HJ. Muscle spasmolytics. In, Hepatotoxicity: The Adverse Effects of Drugs and Other Chemicals on the Liver. 2nd Ed. Philadelphia: Lippincott, 1999. p. 544-45. (Expert review of hepatotoxicity published in 1999 mentions that chlorzoxazone was incriminated in at least 33 instances of liver injury which were usually hepatocellular).
Hibbs RE, Zambon AC. Agents acting at the neuromuscular junction and autonomic ganglia. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s The pharmacological basis of therapeutics, 12th ed. New York: McGraw-Hill, 2011. p. 255-76. (Textbook of pharmacology and therapeutics).
Lindholm L. [Fever, skin and liver reactions in a patient treated with Paraflex comp.] Lakartidningen 1979; 76: 2795-6. Swedish. PMID: 160967 (77 year old woman developed fever, rash after 4 days and cholestatic enzyme elevations after 11 days of a combination of chlorzoxazone, propoxyphene and aspirin without jaundice, resolving in 8 weeks: Case 1).
[Effects on liver of analgesics containing dextropropoxyphene and/or chlorzoxazone.] Lakartidningen 1982; 79: 3823. Swedish. PMID: 7154757 (Reports to Swedish Registry of 13 cases of hepatic injury due to Paraflex Comp that included aspirin and dextropropoxyphene in combination with chlorzoxazone).
Powers BJ, Cattau EL Jr, Zimmerman HJ. Chlorzoxazone hepatotoxic reactions. An analysis of 21 identified or presumed cases. Arch Intern Med 1986; 146: 1183-6. (Case report and review of FDA reports; 55 year old woman developed jaundice 3-4 weeks after starting chlorzoxazone [peak bilirubin 9.0 mg/dL, ALT 720 U/L] and had a positive rechallenge with fever, nausea and jaundice within day of receiving one pill; review of 23 FDA cases, average age 45, latency either <1 month or variable hepatocellular enzyme pattern; 60% jaundiced, 22% fatal). 3521519
Nightingale SL. Chlorzoxazone warning on hepatotoxicity is strengthened. JAMA 1995; 274: 1903. (FDA report that warning on hepatotoxicity has been added to labeling of chlorzoxazone; based largely on analysis of Powers [1986]). 8568972
Chlorzoxazone hepatotoxicity. Med Lett Drugs Ther 1996; 38: 46. (Brief review of chlorzoxazone concludes that it is largely ineffective and can cause liver injury and therefore should be avoided). 8628182
Pillans PI. Drug associated hepatic reactions in New Zealand: 21 years’ experience. N Z Med J 1996; 109: 315-9. (In a large registry of cases of drug induced liver injury from New Zealand, chlorzoxazone is not listed among the 20 most common causes). 8816722
Kronenberg A, Krohenbohl S, Zimmermann A, Streuli R. [Severe hepatocellular damage after administration of paracetamol and chlorzoxazone in therapeutic dosage.] Schweiz Rundsch Med Prax 1998; 87: 1356-60. German. PMID: 9828666 (64 year old man developed jaundice 3-4 weeks after starting chlorzoxazone and acetaminophen combination tablets [bilirubin 35.5 mg/dL, ALT 2796 U/L, Alk P 180 U/L, INR 1.7], with centrozonal necrosis on liver biopsy and ultimate recovery).
Bielecki JW, Schraner C, Briner V, Kuhn M. [Rhabdomyolysis and cholestatic hepatitis under treatment with simvastatin and chlorzoxazone.] Schweiz Med Wochenschr 1999; 129: 514-8. German. PMID: 10322565 (73 year old woman developed myositis and liver injury 2 weeks after starting chlorzoxazone and 1 year after starting simvastatin [bilirubin 8.4 mg/dL, ALT 766 U/L, Alk P 160 U/L], with rapid resolution upon stopping both).
Tanaka E, Terada M, Misawa S. Cytochrome P450 2E1: its clinical and toxicological role. J Clin Pharm Ther 2000; 25: 165-75. (Chlorzoxazone is one of at least 70 substrates metabolized by CYP 2E1; its metabolism can be used as a test of liver function and to assess the activity of this enzyme that is induced by many toxins). 10886461
Chou R, Peterson K, Helfand M. Comparative efficacy and safety of skeletal muscle relaxants for spasticity and musculoskeletal conditions: a systematic review. J Pain Symptom Manage 2004; 28: 140-75. (Systematic review of safety and efficacy of muscle relaxants, including chlorzoxazone for which there is limited or inconsistent data regarding its effectiveness). 15276195
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants done in the US between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, but none were attributed to chlorzoxazone). 15390328
Orellana M, Rodrigo R, Varela N, Araya J, Poniachi KJ, Csendes A, Smok G, et al. Relationship between in vivo chlorzoxazone hydroxylation, hepatic cytochrome P450 2E1 content and liver injury in obese non-alcoholic fatty liver disease patients. Hepatol Res 2006; 34: 57-63. (Chlorzoxazone is metabolized by CYP 2E1 activity and can be used to assess CYP 2E1 activity; among obese patients undergoing bariatric surgery, those with NASH had increased metabolism and increased CYP 2E1 activity). 16321567
Jackson J, Anania FA. Chlorzoxazone as a cause of acute liver failure requiring liver transplantation. Dig Dis Sci 2007; 52: 3389-91. (38 year old woman developed acute liver failure requiring transplantation 6 weeks after starting chlorzoxazone [bilirubin 17.9 mg/dL, ALT 1014 U/L, Alk P not given, INR 3.6]; first published report in ~10 years). 17390222
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were due to chlorzoxazone or other muscle relaxants). 20949552
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributed to chlorzoxazone or other muscle relaxants). 23419359
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, but none were attributed to chlorzoxazone or other muscle relaxants). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-1352.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 5 [0.7%] were attributed to muscle relaxants, including one due to chlorzoxazone: a 46 year old man who developed jaundice 4 weeks after starting chlorzoxazone [bilirubin 3.0 rising to 10.2 mg/dL, ALT 4064 U/L, Alk P 123 U/L], with recovery after stopping). 25754159
Torgersen J, Mezochow AK, Newcomb CW, Carbonari DM, Hennessy S, Rentsch CT, Park LS, et al. Severe acute liver injury after hepatotoxic medication initiation in real-world data. JAMA Intern Med. 2024;184:943-952. (Analysis of the US Veterans Administration electronic health records between 1999 and 2021 identified 1739 hospitalizations for acute liver injury suspected to be due to medications does not mention or list chlorzoxazone). 38913369
Sun C, Zhang M, Guan C, Li W, Peng Y, Zheng J. In vitro and in vivo metabolic activation and hepatotoxicity of chlorzoxazone mediated by CYP3A. Arch Toxicol. 2024;98:1095-1110. (Chlorzoxazone has a dose related toxicity for rat primary hepatocytes that is decreased by inhibition of CYP 3A4, suggesting that an intermediate of its metabolism is responsible for the hepatotoxicity of chlorzoxazone and that it might ameliorated by glutathione or N-acetyl cysteine [NAC]). 38369618
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102. (Among 468 cases of drug-induced liver injury enrolled in a prospective Latin American database none were attributed to chlorzoxazone). 38992407
Chen VL, Rockey DC, Bjornsson ES, Barnhart H, Hoofnagle JH; Drug-Induced Liver Injury Network Investigators. Incidence of idiosyncratic drug-induced liver injury caused by prescription drugs. Drug Saf. 2025;48:151-160. (Analysis of 1284 cases of drug-induced liver injury enrolled in a U.S. prospective study between 2004 and 2023, identified 5 cases [0.4%] attributed to chlorzoxazone one of which was fatal, but the rate of injury could not be calculated because of lack of data on usage: personal communication). 39317916

## OTHER REFERENCE LINKS

1. Recent References on Chlorzoxazone: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Chlorzoxazone/AE%20AND%20Human%5bMH%5d%20AND%20(drug-induced%20liver%20injury%20OR%20jaundice/CI%20OR%20bile%20duct%20diseases/CI%20OR%20liver/DE%20OR%20liver%20diseases/CI%20OR%20hepatitis,%20toxic%5bMH%5d)%20AND%20(%222009/12/01%22%5bEDat%5d:%222999/12/31%22%5bEDat%5d))

2. Trials on Chlorzoxazone: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Chlorzoxazone)